# Lopinavir

## OVERVIEW

### Introduction

Lopinavir is an antiretroviral protease inhibitor used in combination with ritonavir in the therapy and prevention of human immunodeficiency virus (HIV) infection and the acquired immunodeficiency syndrome (AIDS). Lopinavir can cause transient and usually asymptomatic elevations in serum aminotransferase levels and, rarely, clinically apparent, acute liver injury. In HBV or HCV coinfected patients, highly active antiretroviral therapy with lopinavir may result of an exacerbation of the underlying chronic hepatitis B or C.

### Background

Lopinavir (loe pin' a vir) is a peptidomimetic HIV protease inhibitor that acts by binding to the catalytic site of the HIV protease, thereby preventing the cleavage of viral polyprotein precursors into mature, functional proteins that are necessary for viral replication. Lopinavir is usually given in combination with low “booster” doses of ritonavir which improves the pharmacokinetics of lopinavir by slowing its hepatic metabolism. Lopinavir was approved for use in the United States in 2000 for the treatment of HIV infection in adults and children. Lopinavir in fixed combination with ritonavir is available as tablets of 100 mg/25 mg and 200 mg/50 mg and as an oral solution (80/20 mg per mL) for pediatric use generically and under the brand name Kaletra. The recommended dosage of lopinavir in adults is 800 mg daily in combination with 200 mg of ritonavir, either once daily or in two divided doses. Pediatric doses are based upon body weight or body surface area. Common side effects include gastrointestinal upset, nausea, diarrhea, fatigue, headache, and, with long term therapy, dyslipidemia and lipodystrophy.

### Hepatotoxicity

Some degree of serum aminotransferase elevations occur in a high proportion of patients taking lopinavir containing antiretroviral regimens. Moderate-to-severe elevations in serum aminotransferase levels (>5 times the upper limit of normal) are found in 3% to 10% of patients, although rates may be higher in patients with HIV-HCV coinfection. These elevations are usually asymptomatic and self-limited and can resolve even with continuation of the medication. Clinically apparent liver disease due to lopinavir/ritonavir occurs, but is rare. The latency to onset of symptoms or jaundice is usually 1 to 8 weeks and the pattern of serum enzyme elevations varies from hepatocellular to cholestatic or mixed. The injury is usually self-limited; however, fatal cases have been reported. In addition, initiation of lopinavir/ritonavir based highly active antiretroviral therapy can lead to exacerbation of an underlying chronic hepatitis B or C in coinfected individuals, typically arising 2 to 12 months after starting therapy, and associated with a hepatocellular pattern of serum enzyme elevations and increases in serum levels of hepatitis B virus (HBV) DNA or hepatitis C virus (HCV) RNA. Lopinavir therapy has not been clearly linked to lactic acidosis and acute fatty liver that is reported in association with several nucleoside analogue reverse transcriptase inhibitors.

Likelihood score: D (possible, rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the clinical hepatotoxicity from lopinavir may be due to its metabolism by the liver, which is largely by the cytochrome P450 system (CYP3A4), which may result in production of a toxic intermediate. In patients with HBV or HCV coinfection, initiation of highly active antiretroviral therapy including lopinavir may be associated with flares of the underlying chronic hepatitis which are thought to be the result of reconstitution of the immune system, viral interactions or a direct effect of the drug on the hepatitis virus.

### Outcome and Management

The severity of liver injury ranges from mild enzyme elevations to acute liver failure. In typical cases, recovery occurs within 1 to 2 months of stopping lopinavir. Rechallenge may lead to recurrence and should be avoided. There does not appear to be cross reactivity to hepatic injury with other protease inhibitors or antiretroviral agents. The exacerbation of hepatitis B or C that can occur with lopinavir based antiretroviral therapies can be severe and lead to acute liver failure or progressive end stage liver disease. Patients with HCV or HBV coinfection should be monitored prospectively for viral and serum aminotransferase levels and appropriate therapy instituted if possible.

References to loprinavir are included with references to all the HIV protease inhibitors in the overview section of Protease Inhibitors (updated September 2017). Most of the HIV protease inhibitors in clinical use are proteinomimetic drugs and are structurally unrelated.

Drug Class: Antiviral Agents, Antiretroviral Agents

Other Drugs in the Subclass, Protease Inhibitors: Amprenavir, Atazanavir, Darunavir, Fosamprenavir, Indinavir, Nelfinavir, Ritonavir, Saquinavir, Tipranavir

## CASE REPORTS

### Case 1. Serum aminotransferase elevations during lopinavir/ritonavir therapy in a patient with HIV-HCV co-infection.

[Modified from: Kottilil S, Polis MA, Kovacs JA. HIV Infection, hepatitis C infection, and HAART: hard clinical choices. JAMA 2004; 292:243-50. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/15249574)]

A patient with HIV and HCV coinfection was found to have elevations in serum aminotransferase levels 3 months after starting an antiretroviral regimen of abacavir, didanosine, and lopinavir/ritonavir. Aminotransferase levels had been near normal when therapy was started. He was asymptomatic and physical examination was normal, without fever, rash or jaundice. Laboratory tests showed ALT elevations of more than 5 times the upper limit of normal and at least five times baseline values (Table). All antiretroviral agents were stopped and ALT levels decreased. He was restarted on lamivudine, didanosine and lopinavir/ritonavir and serum enzymes remained unchanged. He tested positive for anti-HCV and HCV RNA levels were moderately high (780,000 IU/mL). A liver biopsy showed moderate necroinflammatory activity and bridging hepatic fibrosis. He was treated with peginterferon and ribavirin for 48 weeks in an attempt to eradicate the HCV infection, but serum aminotransferase and HCV RNA did not change. He was maintained on his four drug regimen for HIV infection and remained asymptomatic with CD4 counts above 300/μL and no opportunistic infections.

#### Key Points

Medication: | Lopinavir/ritonavir
Pattern: | Hepatocellular
Severity: | 1+
Latency: | 1 month
Recovery: | 4 weeks
Other medications: | Didanosine, lamivudine, abacavir

#### Laboratory Values

Time After Starting | Time After Stopping | AST (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | HCV RNA (IU/mL)
Pre | | 43 | 158 | 0.6
Started abacavir, didanosine, and lopinavir/ritonavir
12 weeks | 0 | 286 | 158 | 1.1
All antiretrovirals stopped
16 weeks | 14 weeks | 76 | 105 | 0.7
Restarted lamivudine, didanosine, and lopinavir/ritonavir
4 weeks | 0 | 197 | 123 | 1.1 | 780,000
12 months | 0 | 117 | 114 | 1.4 | 772,571
Started peginterferon alfa-2b and ribavirin (48 weeks)
13 months | 0 | 54 | 122 | 1.9
14 months | 0 | 34 | 91 | 1.5 | 887,876
15 months | 0 | 21 | 116 | 1.2 | 513,209
2 years | 0 | 107 | 104 | 0.7 | 179,950
Peginterferon and ribavirin stopped
1 year later | | 134 | 111 | 1.3 | 226,200
Normal Values | | <42 | <116 | <1.2

#### Comment

This patient had HIV-HCV coinfection and the chronic hepatitis C appeared to worsen when highly active antiretroviral therapy, which included lopinavir and low doses of ritonavir, was started. He did not, however, develop symptoms or jaundice. A liver biopsy revealed significant degrees of necroinflammatory activity and fibrosis, and he was treated with a 48 week course of peginterferon and ribavirin. While therapy of the hepatitis C led to transient improvements in serum aminotransferase levels, it had little effect on HCV RNA concentrations and no lasting effect on the disease activity. The worsening of hepatitis C with initiation of antiretroviral therapy has been attributed to reconstitution of the immune system. There is little evidence, however, that antiretroviral therapy leads to an increase in end stage liver disease or worse long term outcomes due to hepatitis C.

### Case 2. Acute cholestatic hepatitis due to lopinavir/ritonavir therapy.

[Modified from: Zell SC. Clinical vignette in antiretroviral therapy: jaundice. J Int Assoc Physicians AIDS Care 2003; 2: 133-9. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/14986514)]

A 35 year old man with long standing HIV infection developed jaundice and itching 17 months after starting a regimen including lopinavir/ritonavir, stavudine and lamivudine. He had been treated successfully for mycobacterium avium intracellulare (MAI) infection, and follow up cultures were negative after a prolonged course of clarithromycin and ethambutol, which had been stopped several months previously. Physical examination showed jaundice, without fever, rash or signs of chronic liver disease. Blood tests showed elevations in serum bilirubin (total 12.6 mg/dL, direct 8.5 mg/dL), alkaline phosphatase (435 U/L) and ALT (200 U/L) (Table). Tests for hepatitis A, B and C were negative. A contrast CT showed no evidence of biliary obstruction. All antiretroviral agents were stopped, but serum alkaline phosphatase levels continued to rise. A liver biopsy showed no evidence of MAI infection or extrahepatic obstruction. After a week, his liver tests begin to improve and he was restarted on antiretroviral therapy using stavudine, lamivudine and nelfinavir. Eight weeks after initial presentation, his serum bilirubin and aminotransferase levels had fallen to normal.

#### Key Points

Medication: | Lopinavir/ritonavir
Pattern: | Cholestatic (R=1.5)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 17 months
Recovery: | 2 months
Other medications: | Stavudine, lamivudine; previously ethambutol and clarithromycin

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
17 weeks | 0 | 200 | 435 | 12.6 | Antiretroviral therapy stopped
| 1 week | | 958 | | Liver biopsy
| 1.5 weeks | 105 | 375 | 3.2 | Discharged
Restarted lamivudine, stavudine, and nelfinavir
19 weeks | 8 weeks | 25 | 319 | 1.1
Normal Values | | <40 | <130 | <1.2

#### Comment

A cholestatic hepatitis arose during antiretroviral therapy, the most likely cause being lopinavir/ritonavir, rather than stavudine and lamivudine which had been tolerated for several years and which was restarted without recurrence of the liver injury. The liver biopsy did not show steatosis and features of mitochondrial injury that would be typical of stavudine. With no other competing diagnosis, the likelihood that this case represented lopinavir/ritonavir induced liver injury is high.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Lopinavir – Kaletra®

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Lopinavir)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Lopinavir | 192725-17-0 | C37-H48-N4-O5 | Lopinavir Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Lopinavir: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Lopinavir/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Lopinavir: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Lopinavir)